# Copanlisib

## OVERVIEW

### Introduction

Copanlisib is an intravenously administered phosphatidylinositol-3 kinase inhibitor that is used to treat relapsed and refractory follicular lymphoma. Copanlisib is associated with a high rate of minor serum enzyme elevations during therapy and has been reported to cause clinically apparent acute liver injury that can be severe and even fatal.

### Background

Copanlisib (koe" pan lis' ib) is an intravenously administered small molecule inhibitor of phosphatidylinositol 3-kinase (PI3K) alpha and delta which are essential components in B cell signaling pathways that drive survival of B cells and their migration to lymph nodes and bone marrow. Inhibition of this pathway inhibits B cell chemotaxis and adherence and reduces cell viability. This pathway is upregulated in many B cell malignancies and is known to be critical for proliferation and survival of leukemia and lymphomatous malignant B lymphocytes. Copanlisib has been shown to result in high rates of objective response in patients with refractory or relapsed follicular lymphoma and was given accelerated approval for this use in the United States in 2017. Copanlisib is available in as lyophilized powder in 60 mg single dose vials under the brand name Aliqopa. The recommended dose is 60 mg given as an intravenous infusion on days 1, 8 and 15 of 28-day cycles. Side effects are common but usually mild-to-moderate in severity, and include nausea, diarrhea, headache, stomatitis, fever, pain, rash, infections, arthralgia and fatigue. Common laboratory abnormalities can include hyperglycemia and cytopenias. Severe adverse events can include marked hypertension, severe diarrhea, neutropenia, infectious and non-infectious pneumonitis, severe cutaneous reactions and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials of copanlisib the rates of serum enzyme elevations during therapy ranged from 23% to 25% but were above 5 times the ULN in only 1% to 2%. Instances of clinically apparent liver injury were not reported in prelicensure trials of copanlisib, but the total number of patients exposed was limited. Since its approval and more general use, there have been no published reports of liver injury with jaundice associated with copanlisib therapy. In contrast, idelalisib, another small molecule inhibitor of PI3K, has been linked to instances of clinically apparent acute liver injury some of which have been fatal.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why copanlisib causes serum enzyme elevations is not known, but may relate to direct toxicity to hepatocytes caused by inhibition of PI3K activity, which plays a central role in many metabolic pathways. Copanlisib is metabolized primarily by the cytochrome P450 system and it is susceptible to drug-drug interactions with strong inducers or inhibitors of CPY 3A.

### Outcome and Management

Serum enzyme elevations are not uncommon during cancer chemotherapy with copanlisib and may occasionally be dose limiting. Monitoring of liver tests is recommended in patients receiving copanlisib. Copanlisib should be temporarily discontinued if ALT or AST values rise above 5 times the ULN and treatment resumed only if and when values improve significantly and then with a careful monitoring. Elevations of aminotransferase values of more than 20 times the ULN, or appearance of jaundice or symptoms of liver injury should trigger permanent discontinuation. There is no published information on cross sensitivity to hepatic injury among the different PI3K kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Copanlisib – Aliqopa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Copanlisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Copanlisib | 1032568-63-0 | C26-H23-N7-O2 | Copanlisib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss copanlisib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Furman RR, Sharman JP, Coutre SE, Cheson BD, Pagel JM, Hillmen P, Barrientos JC, et al. Idelalisib and rituximab in relapsed chronic lymphocytic leukemia. N Engl J Med 2014; 370: 997-1007. (Among 220 patients with relapsed CLL treated in a placebo controlled trial, progression free survival improved with idelalisib and rituximab compared to rituximab alone, but side effects were more common with the combination including ALT or AST elevations [35% vs 19%], which were above 5 times ULN in 5% vs 1% and led to drug discontinuations in some patients, but there were no clinically apparent cases of liver injury). 24450857
Patnaik A, Appleman LJ, Tolcher AW, Papadopoulos KP, Beeram M, Rasco DW, Weiss GJ. First-in-human phase I study of copanlisib (BAY 80-6946), an intravenous pan-class I phosphatidylinositol 3-kinase inhibitor, in patients with advanced solid tumors and non-Hodgkin's lymphomas. Ann Oncol 2016; 27: 1928-40. (Dose ranging studies in patients with diabetes and patients with various forms of cancer identified the maximum tolerated dose and yielded promising results in follicular lymphoma; adverse events were frequent but generally mild-to-moderate in severity, transient and asymptomatic ALT elevations occurring in 34% of subjects but only one had levels above 5 times ULN). 27672108
Greenwell IB, Ip A, Cohen JB. PI3K inhibitors: understanding toxicity mechanisms and management. Oncology (Williston Park) 2017; 31: 821-8. (Review of the toxicities of PI3K inhibitors, their pathogenesis, frequency and management; mentions that idelalisib is associated with autoimmune hepatitis-like reactions that generally respond to drug discontinuation and that liver injury is less frequent and milder with copanlisib therapy). 29179250
Markham A. Copanlisib: first global approval. Drugs 2017; 77: 2057-62. (Review of the mechanism of action, history of development, clinical efficacy and safety of copanlisib does not mention ALT elevations or hepatotoxicity). 29127587
Dreyling M, Santoro A, Mollica L, Leppä S, Follows GA, Lenz G, Kim WS, et al. Phosphatidylinositol 3-kinase inhibition by copanlisib in relapsed or refractory indolent lymphoma. J Clin Oncol 2017; 35: 3898-905. (Among 142 patients with relapsed or refractory indolent lymphoma treated with copanlisib, the objective response rate was 59% and adverse events were frequent including ALT elevations in 23% which were above 5 times ULN in 2 patients [2%]). 28976790
Dreyling M, Morschhauser F, Bouabdallah K, Bron D, Cunningham D, Assouline SE, Verhoef G, et al. Phase II study of copanlisib, a PI3K inhibitor, in relapsed or refractory, indolent or aggressive lymphoma. Ann Oncol 2017; 28: 2169-78. (Among 84 patients with lymphoma treated with copanlisib on days 1, 8 and 15 of 28-day cycles, the objective response rate was 44% in patients with indolent lymphoma and 27% with aggressive lymphoma and common adverse events were hyperglycemia [57%], hypertension [55%] and diarrhea [41%]; ALT elevations occurred in 26% of patients and were above 5 times ULN in 4%). 28633365
Janku F, Yap TA, Meric-Bernstam F. Targeting the PI3K pathway in cancer: are we making headway? Nat Rev Clin Oncol 2018; 15: 273-91. (Thorough review of the role of PI3K in cellular pathways and the promise of specific inhibitors as therapy of metabolic and neoplastic diseases). 29508857
Copanlisib (Aliqopa) for relapsed follicular lymphoma. Med Lett Drugs Ther 2018; 60 (1545): e74-e75. (Concise review of the mechanism of action, clinical efficacy, safety and costs of copanlisib shortly after its approval in the US for relapsed follicular lymphoma mentions adverse effects including hyperglycemia, leukopenia, hypertension and lung infections, but not ALT elevations or hepatotoxicity). 29667951

## OTHER REFERENCE LINKS

1. Recent References on Copanlisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Copanlisib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Copanlisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Copanlisib)